# Desflurane

## OVERVIEW

### Introduction

Desflurane is one of the most commonly used volatile anesthetic agents and has an excellent safety record. Rare single case reports of severe acute liver injury resembling halothane hepatitis due to desflurane have been published.

### Background

Desflurane (des flur' ane) is a widely used major anesthetic agent with rapid onset of action and rapid dispersal. Because it can be irritating to the airway, desflurane is typically used to maintain anesthesia after induction with other agents. Desflurane was initially approved for use in the United States in 1992 and is available generically and under the brand name Suprane. Desflurane must be administered in a controlled situation by a properly trained and credentialed anesthesiologist or nurse anesthetist and is typically given in concentrations up to 6% to 8% with oxygen.

### Hepatotoxicity

Prospective, serial blood testing often demonstrates minor transient elevations in serum aminotransferase levels in the 1 to 2 weeks after major surgery and use of halogenated anesthetics. Appearance of ALT levels above 10 times the upper limit of normal, however, is distinctly unusual and points to significant hepatotoxicity. Clinically apparent, severe hepatic injury from desflurane is very rare, with only isolated case reports having been published and not all of which were very convincing. The injury is marked by acute elevations in serum aminotransferase levels (5- to 50-fold) and appearance of jaundice within 2 to 21 days of surgery. There are usually minimal increases in alkaline phosphatase and gammaglutamyl transpeptidase levels. Jaundice is usually preceded by a day or two of fever and may be accompanied by rash and eosinophilia. The acute liver injury may be self-limited and resolve within 4 to 8 weeks, but can be severe and associated with acute liver failure. A strong risk factor is previous exposure to any of the halogenated anesthetics and particularly a history of halothane hepatitis or unexplained fever and rash after anesthesia with one of these agents. The differential diagnosis of acute liver injury after surgery and anesthesia is often challenging, and a clinical picture similar to desflurane induced hepatitis can be caused by shock or ischemia, sepsis, acetaminophen overdose, acute viral or herpes hepatitis, as well as other idiosyncratic forms of drug induced liver injury.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of desflurane hepatotoxicity is suspected to be similar to that of halothane and associated with creation of reactive intermediates of desflurane. Desflurane is metabolized to a small but variable extent by the microsomal drug metabolizing enzyme CYP 2E1 to a trifluoroacetylated reactive intermediate (TFA) that is capable of binding to multiple intracytoplasmic proteins, forming potentially immunogenic adducts. The TFA adducts induce antibodies that can be detected in patients with desflurane as well as halothane hepatotoxicity and are also found in a proportion of health care workers exposed to the volatile anesthetics.

### Outcome and Management

Severity ranges from mild and transient aminotransferase elevations without symptoms or other evidence of liver injury, to a self limited symptomatic acute hepatitis-like reaction to a severe, acute hepatic failure. The severity and prognosis may relate in part of patient age, being more severe in the elderly and both milder and less common in children. Obesity may also be both a predisposing factor and predictor of outcome. Chronic liver injury from desflurane exposure has not been described. Patients with desflurane induced hepatitis should be cautioned against future exposure to a fluorinated hydrocarbon anesthetic such as halothane, enflurane, isoflurane or sevoflurane.

Drug Class: Halogenated Anesthetics

Other Drugs in the Class: Enflurane, Halothane, Isoflurane, Sevoflurane

## CASE REPORT

### Case 1. Acute liver injury from desflurane anesthesia.

[Modified from: Tung D, Yoshida EM, Wang CS, Steinbrecher UP. Severe desflurane hepatotoxicity after colon surgery in an elderly patient. Can J Anaesth 2005; 52: 133-6. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/15684251)]

An 81 year old overweight woman underwent a right hemicolectomy for colon cancer under desflurane anesthesia and developed clinical evidence of liver disease 6 days later. She had a history of two previous surgeries, but the anesthetics used were not known. She had no history of liver disease or known risk factors or exposures. On postoperative day 6, she became symptomatic with fatigue and was jaundiced, but afebrile. Laboratory testing showed a serum bilirubin of 6.9 mg/dL and marked elevations of ALT with minimal increases in alkaline phosphatase (Table). She had no eosinophilia. She was negative for markers of hepatitis A, B and C and autoantibodies, and liver ultrasound was unrevealing. Over the next several days, she developed evidence of hepatic failure with mild hepatic encephalopathy and INR rising to 2.3. She was treated with methylprednisone (60 mg IV daily for 5 days). She began to recover and laboratory tests had largely returned to close to normal by the time she was discharged 7 weeks after surgery.

#### Key Points

Medication: | Desflurane (6%), 90 min anesthesia time
Pattern: | Hepatocellular (R=>30)
Severity: | 4+ (evidence of acute liver failure, INR>1.5)
Latency: | 6 days
Recovery: | 8-12 weeks
Other medications: | Anesthesia included fentanyl, propofol and rocuronium

#### Laboratory Values

Time after Surgery | ALT (U/L) | Alk P (U/L) | Bilirubin* (mg/dL) | Other
Pre | 15 | 72
0 | Right hemicolectomy under desflurane anesthesia
6 days | 2188 | 149 | 6.9 | Symptoms and jaundice
8 days | 905 | 231 | 9.8
10 days | 567 | 296
12 days | | 277 | 12.5 | Methylprednisone started
14 days | 250 | 252
16 days | 200 | 278 | 6.4
18 days | 189 | 335 | 5.8
20 days | 153 | 316 | 6.8
34 days | 45 | | 2.4
Normal Values | <65 | <200 | <1.2

*Calculated from µmol/L.

#### Comment

This patient had typical halogenated anesthetic associated acute liver injury with a severe course, but ultimate recovery. Fever and eosinophilia are common at the onset of anesthetic induced hepatitis, but are not invariably present. In this patient and others, prednisone was used, but its benefit in this situation has not been proven. Risk factors for halogenated anesthetic hepatotoxicity included older age, overweight and possible previous exposures to halogenated anesthetics.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Desflurane – Generic, Suprane®

DRUG CLASS

Anesthetics, Halogenated

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=desflurane)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Desflurane | 57041-67-5 | C3-H2-F6-O | Desflurane chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 01 January 2018

Zimmerman HJ. Anesthetic agents. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 457-82. (Expert review of hepatotoxicity of anesthetic agents published in 1999; mentions that the newer halogenated anesthetics appear to be safer than halothane but that hints of liver injury from desflurane and sevoflurane have appeared).
Kenna JG. Mechanism, pathology, and clinical presentation of hepatoxicity of anesthetic agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 403-22. (Review of liver injury from anesthetic agents mentions that a few cases of postoperative liver injury have occurred in patients exposed to desflurane).
Patel PM, Patel HH, Roth DM. General anesthetics and therapeutic gases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 527-64. (Textbook of pharmacology and therapeutics)
Weiskopf RB, Eger EI 2nd, Ionescu P, Yasuda N, Cahalan MK, Freire B, Peterson N, et al. Desflurane does not produce hepatic or renal injury in human volunteers. Anesth Analg 1992; 74: 570-4. (Prospective study of 13 young patients given ~7 hours of desflurane anesthesia, with no abnormalities in ALT and AST found during postoperative period). 1554124
Kharasch ED, Thummel KE. Identification of cytochrome P450 2E1 as the predominant enzyme catalyzing human liver microsomal defluorination of sevoflurane, isoflurane, and methoxyflurane. Anesthesiology 1993; 79: 795-807. (Human microsomes used to assess metabolism of sevoflurane: CYP 2E1 was major if not sole enzyme catalyzing defluorination of sevoflurane and others). 8214760
Zaleski L, Abello D, Gold MI. Desflurane versus isoflurane in patients with chronic hepatic and renal disease. Anesth Analg 1993; 76: 353-6. (Prospective study of 20 patients with renal and 20 with hepatic disease given desflurane or isoflurane found no worsening of ALT, AST, Alk P, bilirubin or creatinine). 8424515
Katz J, Magee J, Baker B, Eger EI 2nd. Hepatic necrosis associated with herpesvirus after anesthesia with desflurane and nitrous oxide. Anesth Analg 1994; 78: 1173-6. (76 year old woman developed fever on 6 days and abdominal pain and diarrhea 11 days after desflurance anesthesia [AST rising to 8000 U/L without jaundice] and death on day 14, autopsy showing massive hepatic necrosis due to herpes hepatitis, rather than anesthetic induced liver injury). 8198278
Martin JL, Plevak DJ, Flannery KD, Charlton M, Poerucha JJ, Humphreys CE, Derfus G, Pohl L. Hepatotoxicity after desflurane anesthesia. Anesthesiology 1995; 83: 1125-9. (65 year old woman devleloped fever, rash and arthralgias 12 days after desflurane anesthesia [bilirubin 20.3 rising to 30 mg/dL, ALT 1886 U/L, Alk P 202 U/L], referred for liver transplant but recovered spontaneously; had anti-TFA-modified liver microsomal proteins). 7486167
Njoku D, Laster MJ, Gong DH, Eger EI 2nd, Reed GF, Martin JL. Biotransformation of halothane, enflurane, isoflurane, and desflurane to trifluoroacetylated liver proteins: association between protein acylation and hepatic injury. Anesth Analg 1997; 84: 173-8. (Rats exposed to anesthetics had TFA labeled proteins in hepatocytes: halothane>>enflurane>>isoflurane, but not with desflurane; sera from cases of halothane hepatitis reacted with microsomes from halothane treated rats, but to a lesser extent with desflurane-, enflurane- and isoflurane treated rats). 8989020
Berghaus TM, Baron A, Geier A, Lamerz R, Paumgartner G. Hepatotoxicity following desflurane anesthesia. Hepatology 1999; 29: 613-4. (37 year old woman developed hepatitis 12 days after desflurane anesthesia [bilirubin 29.4 mg/dL, ALT 1776 U/L, Alk P 185 U/L] with evidence of liver failure, but ultimate recovery; had previous history of probable isoflurane hepatitis; anti-TFA present transiently). 10026031
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. ( Among ~50,000 liver transplants done in the US between 1990 and 2002, 137 [0.2%] were done for idiosyncratic drug induced acute liver failure, of which 3 were attributed to halothane and 1 to isoflurane, none to other anesthetics). 15390328
Tung D, Yoshida EM, Wang CS, Steinbrecher UP. Severe desflurane hepatotoxicity after colon surgery in an elderly patient. Can J Anaesth 2005; 52: 133-6. (81 year old woman developed severe hepatocellular injury 6 days after desflurane anesthesia [bilirubin 6.9 rising to 12.5 mg/dL, ALT 2188 U/L, Alk P 149 U/L], with ultimate full recovery. Case 1). 15684251
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (36 years of reporting to Swedish registry identified 103 cases of acute liver failure due to drugs, of which 16 were attributed to halothane [ranking #1] but none to other anesthetics). 16165719
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. ( In WHO database of fatal adverse drug reactions from 1968-2003, there were 4690 reports of fatalities due to drug induced liver injury: halothane ranked fifth in frequency as a cause but most cases were reported before 1991). 16054882
Anderson JS, Rose NR, Martin JL, Eger EI, Njoku DB. Desflurane hepatitis associated with hapten and autoantigen-specific IgG4 antibodies. Anesth Analg 2007; 104: 1452-3, table of contents. (22 year old woman developed fever, jaundice and pruritus 17 to 21 days after desflurane anesthesia [bilirubin 6.2 mg/dL, ALT 347 U/L, Alk P 376 U/L] with rapid recovery; had serum antibodies to TFA and CYP 2E1).17513640
Côté G, Bouchard S. Hepatotoxicity after desflurane anesthesia in a 15 month old child with Mobius syndrome after previous exposure to isoflurane. Anesthesiology 2007; 107: 843-5. (15 month old boy developed ALT of 6,180 U/L with INR of 2.7, on postoperative day 3, after desflurane anesthesia [having two previous exposures to isoflurane], with rapid recovery; bilirubin not mentioned and patient also received acetaminophen). 18073559
Her C. Acetaminophen-induced, not desflurane-induced, hepatotoxicity. Anesthesiology 2008; 109: 570-1. (Letter in response to Côté and Bouchard [2007] suggesting that the liver injury was due to acetaminophen rather than desflurane using Rumack-Matthew nomogram and in view of the high ALT levels). 18719456
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States.Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease collected in the US between 2003 and 2008, two cases were attributed to desflurane and one to sevoflurane; details not given). 18955056
Chin MW, Njoku DB, MacQuillan G, Cheng WS, Kontorinis N. Desflurane-induced acute liver failure. Med J Aust 2008; 189: 293-4. (53 year old woman developed ALT elevation to 943 U/L after initial surgery and desflurane exposure and acute liver failure after the second surgery and exposure [bilirubin not given, ALT 11,600 U/L, INR 3.7, anti-TFA positive], autopsy showing massive necrosis). 18759731
Arslan M, Kurtipek O, Dogan AT, Unal Y, Kizil Y, Nurlu N, Kamaci S, et al. Comparison of effects of anaesthesia with desflurane and enflurane on liver function. Singapore Med J 2009; 50: 73-7. (Prospective study of 40 patients receiving either desflurane or enflurane anesthesia for ALT, AST and glutathione-S-transferase [GST] levels showing elevations in GST but not ALT or AST at 1 hour, 1 and 7 days in enflurane group). 19224088
D evarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/20648003) (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India: none were attributed to anesthetic agents].
Toprak HI, Şahin T, Aslan S, Karahan K, Şanli M, Ersoy MÖ. Effects of desflurane and isoflurane on hepatic and renal functions and coagulation profile during donor hepatectomy. Transplant Proc 2012; 44: 1635-9. (Serial liver tests after right lobe, living donor hepatectomy showed marked elevations [up to 200 times ULN] in ALT and AST by the end of surgery through day 7, resolving by day 30, and increases in INR [1.1 to 1.5] from the end of surgery to day 5, elevations being greater among 40 donors given isoflurane than 40 given desflurane). 22841233
Iorio ML, Cheerharan M, Kaufman SS, Reece-Stremtan S, Boyajian M. Acute Liver Failure Following Cleft Palate Repair: A Case of Therapeutic Acetaminophen Toxicity. Cleft Palate Craniofac J 2013; 50: 747-50. (8 month old boy developed lethargy and seizures 3 days after cleft palate repair under desflurance anesthesia and while receiving acetaminophen for pain [bilirubin 3.1 mg/dL, ALT 12,885 U/L], resolving rapidly after NAC therapy). 22937760
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to anesthetic agents).23419359
Safari S, Motavaf M, Seyed Siamdoust SA, Alavian SM. Hepatotoxicity of halogenated inhalational anesthetics. Iran Red Crescent Med J 2014; 16: e20153. (Review of hepatotoxicity of the volatile halogenated anesthetics). 25593732
Batistaki C, Michalopoulos G, Matsota P, Nomikos T, Kalimeris K, Riga M, Nakou M, Kostopanagiotou G. CYP2E1 immunoglobulin G4 subclass antibodies after desflurane anesthesia. World J Hepatol 2014; 6: 340-6. (Testing of 39 patients for liver biochemical tests and for IgG4 antibody to CYP2E1 before and 4 days after anethesia with desflurane showed no de novo production or rise in titers of the anti-CYP antibody and no evidence of liver injury). 24868327
Lin J, Moore D, Hockey B, Di Lernia R, Gorelik A, Liew D, Nicoll A. Drug-induced hepatotoxicity: incidence of abnormal liver function tests consistent with volatile anaesthetic hepatitis in trauma patients. Liver Int 2014; 34: 576-82. (Retrospective analysis of records from 1556 patients admitted to a trauma unit during 2008 identified 47 cases of possible volatile anesthetic related liver injury, including 12 who developed ALT levels above 200 U/L of whom 11 had fever and 6 eosinophilia, but none were jaundiced or developed acute liver failure). 23944929
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases of which 5 [3%] were attributed to halothane and caused acute liver failure, while no other volatile anesthetic was listed). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 2 were attributed to isoflurane, 1 to sevoflurane, but none to halothane, enflurane or desflurane). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Desflurane: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=desflurane+AND+isoflurane/AE+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+human%5BMH%5D+AND+(%222007/07/01%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Desflurane: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=desflurane)